# Levorphanol

## OVERVIEW

### Introduction

Levorphanol is a synthetic opioid which is used as a narcotic analgesic for moderate-to-severe pain or as a preoperative medication. Levorphanol has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Levorphanol (lee vor’ fa nol) is a fully synthetic opioid that has full agonist activity to the µ type opiate receptors which are found in the central nervous system, but also in the heart, lungs, intestine and skin. Levorphanol also has activity against the κ and δ opioid receptors. Engagement of the opiate receptors results in inhibition of intracellular adenylate cyclase, decrease in calcium influx, and hyperpolarization of neurons with suppression of action potentials. These actions lead to typical analgesic effects of the opioids. Levorphanol is similar to morphine in effect, but is 4 to 8 times as potent and somewhat longer acting. Levorphanol is the levo-rotatory version of morphinan, the parent drug and prototype of many opioids and inhibitors of the NMDA receptor (morphinans). Levorphanol was first approved for use in the United States in 1953. Indications are for moderate-to-severe pain that is that is not responsive to nonnarcotic analgesia and for perioperative sedation and analgesia. It is available in tablets of 2 mg and as a solution for intravenous or intramuscular injection in concentrations of 2 mg/mL generically and under the brand name Levo-dromoran. Typical doses are 2 mg orally every 6 to 8 hours and 1 to 2 mg parenterally every 3 to 6 hours, as needed. Side effects include sedation, respiratory depression, confusion, euphoria, agitation, itching, sweating, abdominal bloating, nausea, vomiting and constipation, adverse effects which are typical of the opioids. Levorphanol is a controlled substance and is classified as a Schedule II drug, indicating that it has medical usefulness, but also a high potential for physical and psychological dependency and abuse.

### Hepatotoxicity

Like most opioid analgesics, levorphanol has not been linked to serum enzyme elevations during therapy or to instances of idiosyncratic, clinically apparent liver injury.

References on the safety and potential hepatotoxicity of levorphanol are given in the 0verview section of the Opioids, last updated April 2019.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Levorphanol – Generic, Levo-Dromoran®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Levorphanol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Levorphanol | 77-07-6 | C17-H23-N-O | Levorphanol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Levorphanol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Levorphanol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Levorphanol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Levorphanol)